# Colony Stimulating Factors

## OVERVIEW

### Introduction

Granulocyte colony stimulating factor (G-CSF) and granulocyte-macrophage colony stimulating factor (GM-CSF) are glycosylated polypeptides that induce an increase in the proliferation and maturation of white blood cells including neutrophils and monocytes-macrophages. Recombinant forms of these colony stimulating factors are used to treat severe neutropenia in patients receiving cancer chemotherapy or undergoing hematopoietic cell transplantation. Recombinant forms include filgrastim (G-CSF) and sargramostim (GM-CSF), both of which are commercially available for therapy of severe neutropenia and bone marrow failure. Neither filgrastim nor sargramostim have been linked to serum enzyme elevations during therapy or to clinically apparent liver injury.

### Background

Filgrastim (fil gra' stim) is a recombinant, non-glycosylated form of the 175 amino acid protein, granulocyte colony stimulating factor (G-CSF) that induces the proliferation and maturation of neutrophils. G-CSF is normally produced by multiple cell types including monocytes, fibroblasts, macrophages and stromal cells. It acts on specific receptors found on granulocyte progenitors and causes an increase in circulating neutrophils. Recombinant filgrastim has been shown to increase total neutrophil counts and to protect, in part, against severe infections in patients with neutropenia for various causes.

Filgrastim was approved for use in the United States in 1991, and current indications are for chemotherapy induced neutropenia, in hematopoietic cell transplantation after myeloablation and in congenital and cyclic neutropenias. Filgrastim is also used in patients undergoing autologous peripheral blood progenitor (stem) cell collection. Filgrastim is available as a solution in single use vials or prefilled syringes (300 and 600 mcg each) for subcutaneous or intravenous administration under the brand name Neupogen. Dose regimens vary by indication (5 or 10 mcg/kg per day) and route of administration (intravenous or subcutaneous).

A pegylated, long acting form of G-CSF (pegfilgrastim) became available in 2002 under the brand name Neulasta which can be given once weekly and has similar efficacy and safety as filgrastim. The current formal indications for pegfilgrastim are limited to prevention of febrile neutropenia during myelosuppressive cancer chemotherapy for non-myeloid malignancies. Pegfilgrastim is available in solution of 6 mg/0.6 mL in prefilled syringes. The typical dose is 6 mg subcutaneously once per chemotherapy cycle. Common side effects of filgrastim and pegfilgrastim include fever, musculoskeletal pain, rash, cough and shortness of breath. Rare side effects include acute allergic reactions, splenic rupture and acute respiratory distress syndrome.

Sargramostim (sar gra' moe stim) is a recombinant form of granulocyte-macrophage stimulating factor (GM-CSF) that stimulates the proliferation and maturation of neutrophils and macrophages. Sargramostim is prepared in yeast (S. cerevisae) and is a 127 amino acid glycoprotein that is 98% identical to native, human GM-CSF. Sargramostim increases the number and activity of circulating neutrophils and monocytes. Sargramostim was approved in the United States in 1991 for use in patients with acute myelogenous leukemia after chemotherapy induced neutropenia. Current indications also include support of patients undergoing hematopoietic cell transplantation as well as for patients undergoing autologous peripheral blood progenitor (stem) cell collection. Sargramostim is available in liquid and lyophilized forms under the brand names Leukine and Prokine. Sargramostim is given either intravenously or subcutaneously daily or three times weekly, the dose and regimen varying by indication. Common side effects include fever, headache, fatigue, bone pain, nausea and weakness, but similar rates of these symptoms are reported with placebo or comparator therapies.

### Hepatotoxicity

Filgrastim and sargramostim have not been linked to instances of significant serum enzyme elevations during therapy and have not been implicated in cases of clinically apparent liver injury. In multiple large prelicensure studies, acute liver injury was not mentioned as an adverse event and serum aminotransferase elevations were elevated in a similar or lower proportion of patients receiving these growth factors than in placebo or comparator arms. G-CSF and GM-CSF are often given to critically ill patients receiving high doses of chemotherapy in whom serum enzyme elevations are common, but which usually can be attributed to the chemotherapy itself or the underlying malignancy. In addition, serum alkaline phosphatase elevations during filgrastim and sargramostim therapy may be from a bone source rather than the liver, in that both agents stimulate the bone marrow and not infrequently cause bone pain. In children, colony stimulating factors can cause hepatomegaly due to extramedullary hematopoiesis. However, since licensure and wide scale use, there have been no published reports of idiosyncratic acute liver injury attributed to filgrastim, pegfilgrastim or sargramostim.

Likelihood scores (recombinant colony stimulating factors): E (unlikely causes of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which the colony stimulating factors might cause liver injury is not known. Both filgrastim and sargramostim are polypeptides and are usually metabolized by the cells on which they act.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) during colony stimulating factor therapy should lead to dose reduction or temporary cessation. Neither filgrastim nor sargramostim have been implicated in cases of severe hepatitis, acute liver failure, chronic hepatitis or vanishing bile duct syndrome. There is no reason to suspect any degree of cross sensitivity in risk for hepatic injury among the various hematologic growth factors and other agents used to treat bone marrow insufficiency.

Drug Class: Hematologic Growth Factors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Filgrastim – Neupogen®

Pegfilgrastim – Neulasta®

Sargramostim – Leukine, Prokine®

DRUG CLASS

Hematologic Growth Factors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Colony%20Stimulating%20Factors)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Filgrastim | 121181-53-1 | Protein | Not Available
Pegfilgrastim | 208265-92-3 | Protein | Not Available
Sargramostim | 123774-72-1 | Protein | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 30 October 2017

Zimmerman HJ. Hormonal derivatives and related drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp 555-88. (Review of hepatotoxicity published in 1999; the hematologic growth factors are not specifically mentioned).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook on hepatotoxicity; hematologic growth factors are not discussed).
Kaushansky K, Kipps TJ. Hematopoietic agents: growth factors, minerals and vitamins. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1067-99. (Textbook of pharmacology and therapeutics).
Nemunaitis J, Rabinowe SN, Singer JW, Bierman PJ, Vose JM, Freedman AS, Onetto N, et al. Recombinant granulocyte-macrophage colony-stimulating factor after autologous bone marrow transplantation for lymphoid cancer. N Engl J Med 1991; 324: 1773-8. (Among 128 patients with lymphoma receiving chemotherapy and hematopoietic cell transplantation who were given prophylaxis with sargramostim [GM-CSF] or placebo, the duration of neutropenia and hospitalization were shorter with GM-CSF, but infection rates and survival were not different and there were no differences in frequency of side effects; no mention of ALT elevations or hepatotoxicity). 1903847
Granulocyte colony-stimulating factors. Med Lett Drugs Ther 1991; 33 (847): 61-3. (Concise review of the efficacy and safety of recombinant granulocyte colony stimulating factors, including filgrastim and sargramostim, shortly after their approval in the US for prophylaxis against infections during cancer chemotherapy, mentions that transient elevations in serum aminotransferase and alkaline phosphatase levels can occur with either agent). 1710761
Gorin NC, Coiffier B, Hayat M, Fouillard L, Kuentz M, Flesch M, Colombat P, et al. Recombinant human granulocyte-macrophage colony-stimulating factor after high-dose chemotherapy and autologous bone marrow transplantation with unpurged and purged marrow in non-Hodgkin's lymphoma: a double-blind placebo-controlled trial. Blood 1992; 80: 1149-57. (Among 91 patients with lymphoma undergoing chemotherapy and hematopoietic cell transplantation who were treated with sargramostim or placebo found shorter periods of neutropenia with the GM-CSF, but no difference in rates of infection or survival; adverse events attributed to GM-CSF included bone pain, fever and capillary leak syndrome). 1515637
Kellihan MJ. Drug formulary review process for sargramostim and filgrastim: focus on analysis of adverse drug reactions. Clin Ther 1993; 15: 927-37. (Comparison of published and unpublished reports on sargramostim and filgrastim showed similar rates of adverse events including “liver damage”, but no details given). 7505717
Dale DC, Bonilla MA, Davis MW, Nakanishi AM, Hammond WP, Kurtzberg J, Wang W, et al. A randomized controlled phase III trial of recombinant human granulocyte colony-stimulating factor (filgrastim) for treatment of severe chronic neutropenia. Blood 1993; 81: 2496-502. (Among 120 patients with chronic neutropenia treated with filgrastim, most patients had a clinically important increase in neutrophil counts within a few days of starting therapy and subsequent decreased rate of infections; side effects were generally mild, but included bone pain, headache, fever and splenic enlargement [averaging 34%]; no mention of ALT elevations or hepatotoxicity). 8490166
Stahel RA, Jost LM, Cerny T, Pichert G, Honegger H, Tobler A, Jacky E, Fey M, Platzer E. Randomized study of recombinant human granulocyte colony-stimulating factor after high-dose chemotherapy and autologous bone marrow transplantation for high-risk lymphoid malignancies. J Clin Oncol 1994; 12: 1931-8. (Among 43 patients with lymphomas undergoing chemotherapy and hematopoietic cell transplantation [HCT] given filgrastim in two different doses, efficacy and tolerance were similar and the only adverse events attributed to the GCSF were bone pain and skin reactions). 7521907
Stahel RA, Jost LM, Honegger H, Betts E, Goebel ME, Nagler A. Randomized trial showing equivalent efficacy of filgrastim 5 micrograms/kg/d and 10 micrograms/kg/d following high-dose chemotherapy and autologous bone marrow transplantation in high-risk lymphomas. J Clin Oncol 1997; 15: 1730-5. (Among 86 patients with lymphomas undergoing chemotherapy and hematopoietic cell transplantation [HCT] given filgrastim in two different doses, efficacy and tolerance were similar and were largely attributed to HCT). 9164179
Skowron G, Stein D, Drusano G, Melbourne K, Bilello J, Mikolich D, Rana K, et al. The safety and efficacy of granulocyte-macrophage colony-stimulating factor (Sargramostim) added to indinavir- or ritonavir-based antiretroviral therapy: a randomized double-blind, placebo-controlled trial. J Infect Dis 1999; 180: 1064-71. (Among 20 patients with HIV infection given sargramostim or placebo 3 times weekly for 8 weeks, side effects included fever, nausea, injection site reactions and neutrophilia; no mention of ALT elevations or hepatotoxicity). 10479132
Milkovich G, Moleski RJ, Reitan JF, Dunning DM, Gibson GA, Paivanas TA, Wyant S, et al. Comparative safety of filgrastim versus sargramostim in patients receiving myelosuppressive chemotherapy. Pharmacotherapy 2000; 20: 1432-40. (Retrospective analysis of 490 patients treated with filgrastim or sargramostim for prophylaxis against infection during cancer chemotherapy found that adverse reactions including bone pain, fatigue and unexplained fever were slightly more frequent with sargramostim than filgrastim; no mention of ALT elevations or hepatotoxicity). 11130215
Bennett JM, Young MS, Liesveld JL, Paietta E, Miller KB, Lazarus HM, Marsh RD, et al. Phase II study of combination human recombinant GM-CSF with intermediate-dose cytarabine and mitoxantrone chemotherapy in patients with high-risk myelodysplastic syndromes (RAEB, RAEBT, and CMML): an Eastern Cooperative Oncology Group Study. Am J Hematol 2001; 66: 23-7. (Among 10 patients with severe myelodysplastic syndromes treated with cytarabine, mitoxantrone and sargramostim prophylaxis, hepatic toxicity occurred in 7, marked by high serum bilirubin [2.2 to 22.4 mg/dL] despite normal AST in all except one, leading to an early discontinuation of the trial, but attributed to the anticancer drugs rather than GM-CSF). 11426487
Pegfilgrastim(Neulasta) for prevention of febrile neutropenia. Med Lett Drugs Ther 2002; 44 (1130): 44-5. (Review of the efficacy and safety of pegfilgrastim for prophylaxis against infections in neutropenic patients shortly after its US approval for use, mentions that side effects are similar to those with filgrastim and can include bone pain [26%] and reversible elevations of serum Alk P). 12011756
Vose JM, Crump M, Lazarus H, Emmanouilides C, Schenkein D, Moore J, Frankel S, et al. Randomized, multicenter, open-label study of pegfilgrastim compared with daily filgrastim after chemotherapy for lymphoma. J Clin Oncol 2003; 21: 514-9. (Among 66 patients receiving chemotherapy for lymphoma given filgrastim or pegfilgrastim as prophylaxis against infection, side effects were similar with the two CSFs, but bone pain was more frequent with the pegylated product; no mention of ALT elevations or hepatotoxicity). 12560443
Spitler LE, Weber RW, Allen RE, Meyer J, Cruickshank S, Garbe E, Lin HY, et al. Recombinant human granulocyte-macrophage colony-stimulating factor (GM-CSF, sargramostim) administered for 3 years as adjuvant therapy of stages II (T4), III, and IV melanoma. J Immunother 2009; 32: 632-7. (Among 98 patients with melanoma given cyclic therapy with sargramostim for up to 3 years, side effects were mostly injection site reactions and flu-like symptoms, and there were no serious adverse events clearly linked to therapy and no mention of ALT elevations or hepatotoxicity). 19483646
Takazoe M, Matsui T, Motoya S, Matsumoto T, Hibi T, Watanabe M. Sargramostim in patients with Crohn's disease: results of a phase 1-2 study. J Gastroenterol 2009; 44: 535-43. (Among 11 patients with Crohn disease treated with sargramostim once daily for 4 or 8 weeks, side effects included injection site reactions, fever, back and bone pain, but there were no “clinically significant laboratory abnormalities” or mention of hepatotoxicity). 19352588
Kilic SC, Alaygut D, Unal E, Koç E, Patiroglu T. Acute colchicine intoxication complicated with extramedullary hematopoiesis due to filgrastim in a child. J Pediatr Hematol Oncol 2014; 36: e460-2. (3 year old boy took an overdose of his mother's colchicine and developed nausea, vomiting and diarrhea followed by rhabdomyolysis, acidosis, neutropenia and sepsis, which was treated with recombinant G-CSF and was followed by leukocytosis and hepatomegaly which the authors attributed to extramedullary hematopoiesis). 24309614
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN prospective study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury seen over a ten year period at 8 US medical centers, none were attributed to the recombinant colony stimulating factors). 25754159
Engelmann C, Splith K, Berg T, Schmelzle M. Effects of granulocyte-colony stimulating factor (G-CSF) on stem cell mobilization in patients with liver failure. Eur J Intern Med 2016; 36: e37-e39. (Among 13 patients with various forms of acute liver failure treated with filgrastim [12 doses over 26 days], 9 survived; adverse events were not mentioned). 27745994

## OTHER REFERENCE LINKS

1. Recent References on Colony Stimulating Factors: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Colony%20Stimulating%20Factors+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Colony Stimulating Factors: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Colony%20Stimulating%20Factors)